# Xanthine Derivatives

## OVERVIEW

The xanthine derivatives are agents that resemble natural occurring xanthines such as caffeine, theobromine and methylxanthines. These are plant alkaloids and components of coffee, tea and chocolate. The major pharmacologic actions of the xanthines are inhibition of tissue phosphodiesterases which increases cellular cyclic AMP levels by inhibition of its breakdown and metabolism. The xanthines also are adenosine receptor antagonists. Finally, xanthines may have antiinflammatory effects, either via release of antiinflammatory cytokines or modulation of gene transcription or activation of histone dacetylase. All of these actions may be important in their effects of bronchial tree, resulting in relaxation of smooth muscle. The major use of xanthine derivatives are for relief of bronchospasm caused by asthma or chronic obstructive lung disease. The most widely used xanthine is theophylline.

The xanthines also have other activities mediated by their effects on different tissue phosphodiesterases including inhibition of platelet function and arterial vasodilation. These activities have potential use in preventing arterial thrombosis and thus prevention of myocardial infarction and stroke. The vasodilation caused by xanthines has been used to treat intermittent claudication (pentoxifylline). Xanthines also stimulate muscle and cardiac cells and neurons. Xanthines can cause a mild diuresis.

The xanthines have many minor side effects (anxiety, nervousness, tremor, headache, dizziness) but are largely well tolerated in the doses used to treat asthma and chronic bronchitis. The xanthines are very rare causes of drug induced liver injury, most instances being mild and due to a hypersensitivity reaction or due to hepatic ischemia associated with overdose.

Drug Class: Antiasthmatic Agents

Drugs in the Subclass, Xanthine Derivatives: Theophylline, Pentoxifylline, Caffeine